# Methsuximide

## OVERVIEW

### Introduction

Methsuximide is a succinimide-based anticonvulsant similar to ethosuximide that is used for absence (petit mal) seizures in both adults and children. Methsuximide was associated with hepatic injury in experimental animals, but has not been linked to serum enzyme elevations during treatment or to cases of clinically apparent liver injury with jaundice.

### Background

Methsuximide (meth sux’ i mide: also called mesuximide) is a succinimide derivative and anticonvulsant that is used to treat absence (petit mal) seizures. The succinimide anticonvulsants reduce low threshold calcium currents in thalamic neurons, and suppress the paroxysmal spike and wave activity that is associated with lapses of consciousness that occur with absence seizures. Methsuximide was first approved in 1957 for use alone or in combination with other agents to treat absence seizures. Methsuximide is no longer in common use, having been replaced by ethosuximide, the most active of the succinimide anticonvulsants and first line therapy for petit mal epilepsy. Nevertheless, methsuximide is still available, generically and under the brand name Celontin as capsules of 150 and 300 mg. The recommended initial dose in adults and children above the age of 6 years is 300 mg once daily, with gradual dose escalation weekly based upon tolerance and effect to a maximum of 1200 mg daily. Common side effects include dizziness, somnolence, ataxia, fatigue, irritability, anorexia and epigastric discomfort.

### Hepatotoxicity

Prospective studies suggest that chronic methsuximide therapy is not accompanied by significant elevations in serum aminotransferase levels, although it has been shown to have hepatotoxicity in animals. Clinically apparent hepatotoxicity from methsuximide has not been reported, although hypersensitivity reactions with fever and rash are not uncommon (1% to 5%). The product label for methsuximide warns of hepatic dysfunction and recommends periodic liver function studies. Nevertheless, clinically apparent liver injury from methsuximide must be very rare, if it occurs at all.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

Methsuximide is metabolized to inactive intermediates in the liver via the cytochrome P450 system (CYP 3A4) and is susceptible to many drug-drug interactions.

### Outcome and Management

While there have been no reported instances of liver injury from methsuximide, monitoring for liver tests is recommended. While there may be cross reactivity to hypersensitivity reactions or liver injury between methsuximide and ethosuximide, there is no evidence of cross reactivity with the aromatic anticonvulsants.

Drug Class: Anticonvulsants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Methsuximide – Generic, Celontin®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Methsuximide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Methsuximide | 77-41-8 | C12-H13-N-O2 | Chemical Structure for Methsuximide
Ethosuximide | 77-67-8 | C7-H11-N-O2 | Ethosuximide chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 July 2016

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999; methsuximide is not discussed).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-42. (Review of anticonvulsant induced liver injury; methsuximide is not discussed).
McNamara JO. Pharmacology of the epilepsies. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 583-607. (Textbook of pharmacology and therapeutics).
Livingston S, Pauli L. Celontin (PM-396) in the treatment of epilepsy. Pediatrics 1957; 19 (4 Pt 1): 614-8. (Among 136 patients with various types of poorly controlled seizures treated with methsuximide for 6-15 months, beneficial results were found largely in those with minor motor and psychomotor seizures, and routine blood tests were reported to remain normal). 13419432
French EG, Rey-Bellet J, Lennox WG. Methsuximide in psychomotor and petit-mal seizures. N Engl J Med 1958; 258: 892-4. (Among 106 adults and children with varying types of poorly controlled seizures treated with methsuximide, 30 dropped out and 49 [48%] reported some degree of improvement, side effects being drowsiness, nausea and vomiting, constipation, rash [n=9], confusion and headaches; no mention of jaundice or hepatotoxicity). 13541681
Karch SB. Methsuximide overdose. Delayed onset of profound coma. JAMA 1973; 223: 1463-5. (18 year old girl with epilepsy took an overdose of 10 g of methsuximide and developed dizziness, followed by somnolence and then deep coma 9 hours later, persisting for 72 hours; ALT, AST, Alk P and bilirubin levels were normal). 4740029
Reynolds NC Jr, Miska RM. Safety of anticonvulsants in hepatic porphyrias. Neurology 1981; 31: 480-4. (Mentions that both methsuximide and ethosuximide have been associated with triggering attacks of acute intermittent porphyria). 876020
Wilder BJ, Buchanan RA. Methsuximide for refractory complex partial seizures. Neurology 1981; 31: 741-4. (Among 21 patients with refractory complex partial seizures treated with methsuximide, 8 had a complete and 7 a partial response; side effects included somnolence, headache, ataxia, skin rash, nausea and malaise, but “most were not serious”; no mention of hepatotoxicity or serum enzyme elevations). 6894634
Coulter DL. Ethosuximide-induced liver dysfunction. Arch Neurol 1983; 40: 393-4. (1 year old boy developed ALT elevations one month after ethosuximide was added to a chronic regimen of valproate and phenobarbital that continued to worsen after stopping valproate [bilirubin normal, ALT 69 rising 229 U/L, GGT 175 U/], resolving rapidly when ethosuximide was stopped). 6847455
Browne TR, Feldman RG, Buchanan RA, Allen NC, Fawcett-Vickers L, Szabo GK, Mattson GF, et al. Methsuximide for complex partial seizures: efficacy, toxicity, clinical pharmacology, and drug interactions. Neurology 1983; 33: 414-8. (Among 26 adults with poorly controlled, complex partial seizures treated with methsuximide, 8 had a clinical response and continued on therapy; side effects included drowsiness, gastrointestinal complaints, hiccups, irritability, headache and ataxia, but there was “no serious idiosyncratic hemopoietic, hepatic, or renal toxicity”). 6403891
Tennison MB, Greenwood RS, Miles MV. Methsuximide for intractable childhood seizures. Pediatrics 1991; 87: 186-9. (Among 23 children with various forms of intractable seizures treated with methsuximide, 15 had a 50% or greater decrease in seizures; 4 had side effects requiring discontinuation, include 2 with rash; no details provided). 1987529
Hurst DL. Methsuximide therapy of juvenile myoclonic epilepsy. Seizure 1996; 5: 47-50. (Among 5 adolescent girls with juvenile myoclonic epilepsy treated with methsuximide, all became seizure free and 4 could stop all other anticonvulsants; there were no serious adverse events). 8777552
Knowles SR, Shapiro LE, Shear NH. Anticonvulsant hypersensitivity syndrome: incidence, prevention and management. Drug Saf 1999; 21: 489– 501. (Review of anticonvulsant hypersensitivity syndrome: triad of fever, rash and internal organ injury occurring 1-8 weeks after exposure to anticonvulsant, liver being most common internal organ involved. Occurs in 1:1000-1:10,000 initial exposures to phenytoin, carbamazepine, phenobarbital or lamotrigine, unrelated to dose, perhaps predisposed by valproate; liver injury arises 1-4 weeks after onset of rash and ranges in severity from asymptomatic ALT elevations to icteric hepatitis to ALF; high mortality rate with jaundice; other organs include muscle, kidney, brain, heart and lung. Pseudolymphoma syndrome and serum sickness like syndrome are separate complications of anticonvulsants; role of corticosteroids uncertain; cross reactivity among the agents should be assumed; methsuximide is not mentioned). 10612272
Hamer HM, Morris HH. Hypersensitivity syndrome to antiepileptic drugs: a review including new anticonvulsants. Clevel Clin J Med 1999; 66: 239-45. (Clinical review of anticonvulsant syndrome, which occurs in 1-5/10,000 users, higher risk in African Americans and affected siblings; liver involvement common, but most cases are anicteric; other manifestations include facial edema, lymphadenopathy, bone marrow aplasia, pseudolymphoma, thyroiditis, interstitial nephritis, switching to valproate, levetiracetam or benzodiazepines is safe; methsuximide is not mentioned). 10199060
Sigler M, Strassburg HM, Boenigk HE. Effective and safe but forgotten: methsuximide in intractable epilepsies in childhood. Seizure 2001; 10: 120-4. (Among 112 children with intractable epilepsy treated with methsuximide, there were no serious or irreversible adverse events and 50% had a decrease in seizure frequency). 11407955
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, of which 10 were attributed to phenytoin, 10 to valproate and 1 to carbamazepine, but none to ethosuximide or methsuximide). 15390328
Björnsson E. Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scan 2008; 118: 281-90. (Review of all anticonvulsants; mentions that there is no known clinically significant hepatotoxicity associated with ethosuximide). 18341684
Penovich PE, Willmore LJ. Use of a new antiepileptic drug or an old one as first drug for treatment of absence epilepsy. Epilepsia 2009; 50 Suppl 8: 37-41. (Review of the therapy of absence seizures, mentions that side effects of ethosuximide "tend to be a challenge"; no mention of methsuximide or of hepatotoxicity). 19702732
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 11 [8%] were due to anticonvulsants, including phenytoin [8], valproate [2], and carbamazepine [3], but none were attributed to ethosuximide or methsuximide). 20949552
Hoepner R, May TW, Rambeck B, Ottenottebrock H, Valentin R, Brandt C. Symptoms and course of intoxication with mesuximide--a case report. Epilepsy Behav 2012; 25: 129-30. (31 year old woman on multiple antiepileptic drugs developed worsening somnolence and was found to have abnormally elevated methsuximide levels; no mention of ALT elevations or hepatotoxicity). 22818365
Knowles SR, Dewhurst N, Shear NH. Anticonvulsant hypersensitivity syndrome: an update. Expert Opin Drug Saf 2012; 11: 767-78. (Updated review of anticonvulsant hypersensitivity syndrome associated with phenytoin, phenobarbital, lamotrigine and carbamazepine and rarely with zonisamide, valproate and oxcarbazepine; methsuximide is not mentioned). 22794330
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury from the US enrolled in a prospective database between 2004 and 2012, anticonvulsants were implicated in 40 cases, including one attributed to ethosuximide, but none to methsuximide). 25754159
Drugs for epilepsy. Treat Guidel Med Lett 2013; 11: 9-18. (Concise review of indications and side effects of anticonvulsants; mentions that ethosuximide is the first line drug recommended for treatment of absence seizures, but does not mention methsuximide). 23348233

## OTHER REFERENCE LINKS

1. Recent References on Methsuximide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Methsuximide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Methsuximide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Methsuximide)